# Satralizumab

## OVERVIEW

### Introduction

Satralizumab is a cytolytic monoclonal antibody to the interleukin 6 receptor that is used to treat adolescents and adults with neuromyelitis optica spectrum disorder accompanied by an autoantibody to aquaporin-4. Satralizumab therapy has been associated with serum aminotransferase elevations during therapy but has not been linked to instances of clinically apparent liver injury.

### Background

Satralizumab (sa’ tra liz’ ue mab) is a humanized, cytolytic monoclonal antibody to the interleukin 6 receptor (IL-6r) that is used to treat adolescents and adults with neuromyelitis optica spectrum disorder (NMOSD), a rare and severe neurologic disease marked by bilateral optic neuritis and transverse myelitis and accompanied by a distinctive autoantibody to aquaporin-4 (antiAQP4), a water channel protein found on the surface of astrocytes. NMOSD resembles multiple sclerosis (MS) in many clinical features including spontaneous relapses and remissions. NMOSD differs from MS in the absence of typical brain findings on magnetic resonance imaging and by the presence of a distinctive autoantibody against aquaporin-4 (antiAQP4), a water channel protein found on the surface of astrocytes. Satralizumab dramatically lowers production of the proinflammatory cytokine IL-6 which plays an important role in the inflammatory reactions in NMOSD. In several randomized controlled trials, satralizumab therapy was associated with a significant decrease in relapse rates in patients with NMOSD. Satralizumab was approved in the United States for treatment of adolescents and adults with neuromyelitis optica spectrum disorder positive for anti-AQP4 in 2020. Satralizumab is available in solution in single dose prefilled syringes of 120 mg/mL under the brand name Enspryng. The recommended dosage is 120 mg by subcutaneous injection at weeks 0, 2, and 4, followed by maintenance doses of 120 mg every 4 weeks. Patients should be screened for hepatitis B and tuberculous and for routine liver tests before starting therapy and be given any needed live viral vaccines beforehand. In prelicensure trials, common adverse events included symptoms of upper respiratory tract infection, headache, gastrointestinal upset, rash, arthralgia, extremity pain, fatigue, nausea, pruritus, depression, neutropenia and liver test abnormalities. Potentially serious adverse events include severe bacterial or opportunistic infections, hypersensitivity reactions, and anaphylaxis. Because it lowers IL-6 levels, satralizumab may cause reactivation of tuberculosis, hepatitis B, and herpes virus infections, and possibly lead to progressive multifocal leukoencephalitis.

### Hepatotoxicity

In registration, controlled trials, serum ALT elevations occurred in 20% to 37% of satralizumab vs 13% to 15% of placebo recipients but were rarely above 3 times the upper limit of normal (ULN). In these trials, satralizumab was discontinued in only two patients due to elevated liver enzymes, and one case was confounded by use of amoxicillin-clavulanate. No liver enzyme elevations were associated with bilirubin elevations. Although the product label carries a warning of liver enzyme elevation, there have been no case reports of clinically apparent liver injury attributed to its use. The monoclonal antibodies directed against IL-6 actions have generally been free of hepatotoxicity but have been considered possible causes of reactivation of hepatitis B for which reason prescreening for hepatitis B status is recommended.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury attributable to reactivation of hepatitis B).

### Mechanism of Injury

The causes of the mild liver test abnormalities during satralizumab therapy are not clearly known but appear to be related to the underlying condition or comorbidities. Satralizumab can cause hypersensitivity reactions including urticaria and rash, and liver injury might be a part of the immunoallergic reaction. Cases of reactivation of hepatitis B were not observed during prelicensure studies and should not occur with adequate prescreening and prophylaxis against reactivation.

### Outcome and Management

The product label for satralizumab recommends monitoring of routine liver tests during therapy every 4 weeks for 3 months, followed by every 3 months for one year and thereafter as clinically indicated. Despite this, marked elevations of serum ALT levels during therapy are rare, and long term studies have reported no instances of drug induced liver injury. The product label also recommends screening for hepatitis B before starting therapy and, if positive results are obtained, obtaining advice from a hepatologist regarding prophylaxis. While reactivation of hepatitis B has not been reported with satralizumab, most patients are screened for evidence of infection before starting therapy and given appropriate prophylaxis. If de novo elevations of serum aminotransferase levels above 5 times the ULN or baseline values arise during therapy, temporary discontinuation and evaluation for other possible causes of liver injury is appropriate, restarting therapy only when values return to normal or near normal and with careful subsequent monitoring.

Drug Class: Immunomodulatory Agents; Neurologic Disease Agents; Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Satralizumab – Enspryng®

DRUG CLASS

Immunomodulatory Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Satralizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Satralizumab | 1535963-91-7 (https://pubchem.ncbi.nlm.nih.gov/substance/381127598) | Monoclonal Antibody | Not Available

## SELECTED ANNOTATED BIBLIOGRAPHY

References updated: 14 May 2024

Abbreviations: AntiAQP4, antibody to aquaporin-4NMOSD; neuromyelitis optica spectrum disorder (NMOSD); ULN, upper limit of the normal range.

FDA. Clinical Review. 2020.
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/761149Orig1s000MedR.pdf (FDA Summary of the data the safety and efficacy of satralizumab, submitted in support of the application for approval as therapy of neuromyelitis optica spectrum disorder, mentions ALT elevations in 19.5% to 36.5% [none above 5 times ULN] of satralizumab-treated versus 12.5% to 14.5% on placebo and bilirubin elevations in 8% to 12% vs none with placebo, but there were no ALT elevations accompanied by jaundice).
Yamamura T, Kleiter I, Fujihara K, Palace J, Greenberg B, Zakrzewska-Pniewska B, Patti F, et al. Trial of satralizumab in neuromyelitis optica spectrum disorder. N Engl J Med. 2019;381:2114-2124. (Among 83 patients with NMOSD treated with satralizumab or placebo for an average of 2 years, relapses occurred I 20% vs 43% while adverse event rates were similar [95% vs 90%] including severe adverse events [17% vs 21%]; no mention of ALT elevations or hepatotoxicity). 31774956
Traboulsee A, Greenberg BM, Bennett JL, Szczechowski L, Fox E, Shkrobot S, Yamamura T, et al. Safety and efficacy of satralizumab monotherapy in neuromyelitis optica spectrum disorder: a randomised, double-blind, multicentre, placebo-controlled phase 3 trial. Lancet Neurol. 2020;19:402-412. (Among 95 patients with NMOSD treated with satralizumab or placebo, relapse rates were 30% vs 50% while adverse event rates were higher with monoclonal therapy [92% vs 75%] and serious adverse events [27% vs 6%] but there were no differences in rates of serious infections or injection reactions, and no anaphylactic reactions; no mention of ALT elevations or hepatotoxicity). 32333898
Heo YA. Satralizumab: first approval. Drugs. 2020;80:1477-1482. (Review of the mechanism of action, pharmacology, clinical efficacy and toxicity of satralizumab shortly after its approval for therapy of NMOSD; no mention of hepatotoxicity or ALT elevations). 32797372
Levy M, Fujihara K, Palace J. New therapies for neuromyelitis optica spectrum disorder. Lancet Neurol. 2021;20:60-67. (Review of the mechanisms of action, clinical efficacy, and safety of 3 new therapies for NMOSD including eculizumab [targeting complement activation], satralizumab [targeting IL6], and inebilizumab [targeting B cells]; no mention of ALT elevations or hepatotoxicity). 33186537
Giglhuber K, Berthele A. Adverse events in NMOSD therapy. Int J Mol Sci. 2022;23:4154. (Review of side effects and toxicities of drugs used to treat NMOSD, mentions hepatotoxicity of azathioprine and mild, transient serum aminotransferase elevations with mycophenolate, tocilizumab, satralizumab, and inebilizumab without evidence for clinically significant drug induced liver injury). 35456972
Yamamura T, Weinshenker B, Yeaman MR, De Seze J, Patti F, Lobo P, von Büdingen HC, et al. Long-term safety of satralizumab in neuromyelitis optica spectrum disorder (NMOSD) from SAkuraSky and SAkuraStar. Mult Scler Relat Disord. 2022;66:104025. (Among 161 patients with NMSOD treated with satralizumab in two open label extension studies for a median of 4.4 years, adverse events did not increase with time, there were no treatment related deaths, and ALT elevations arose in 37% of patients but were above 5 times ULN in only 1%, and there were no cases of drug induced liver injury or ALT elevations with jaundice). 36007339

## OTHER REFERENCE LINKS

Recent References on Satralizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Satralizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Satralizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Satralizumab)